# Vitamins

## OVERVIEW

### Introduction

Vitamins are defined as essential constituents of the diet that are not synthetized by humans. Some vitamins are synthesized to some extent, but in amounts that are inadequate to support health. Most vitamins were discovered during the investigation of severe deficiencies such as scurvy (vitamin C), rickets (vitamin D), megaloblastic anemias (vitamin B12 and folate), pellagra (niacin) and beriberi (thiamine). Most vitamins are not one specific molecule, but a group of related compounds that are capable of providing the necessarily essential molecular ingredient (thus nicotinic acid and nicotinamide for niacin and phytonadione and menadione for vitamin K). The recommended daily amounts or recommended daily intakes of most vitamins have been established by the Food and Nutrition Board of the Institute of Medicine. These recommendations provide guidance for standard dosing of vitamins in dietary supplements and multivitamin preparations. Approximately one-third of adult Americans take multivitamins and a substantial number take specific vitamin supplements.

### Hepatotoxicity

When taken within the range of recommended amounts, vitamins have not been implicated in cases of drug induced liver injury. Even in high doses, most vitamins have few adverse events and do not harm the liver. Many vitamins are normally concentrated in, metabolized by and actually stored in the liver, particularly the fat soluble vitamins. The two exceptions to the lack of harm to the liver by higher doses of vitamins are vitamin A and niacin, both of which can cause distinctive forms of liver injury when taken in high doses.

Specific links to discussions of the risks of liver injury from specific vitamins are given below. The water soluble B vitamins are discussed together, whereas the fat soluble vitamins (A, D, E and K) and niacin, folate, vitamin C and vitamin K are discussed in separate documents. Specific examples of hepatotoxicity are given in the sections on vitamin A and niacin.

- Folic Acid (Folate, Folinic Acid)
- Vitamin A & Retinoids
  - Vitamin A
  - Acitretin, Etretinate, Isotretinoin
  - Bexarotene
- Vitamin B
  - Biotin (B5)
  - Choline
  - Cyanocobalamin (B12)
  - Niacin (B3, Nicotinamide, Nicotinic Acid)
  - Pantothenic Acid (B7)
  - Pyridoxine (B6)
  - Riboflavin (B2)
  - Thiamine (B1)
- Vitamin C (Ascorbic Acid)
- Vitamin D (Cholecalciferol, Ergocalciferol)
- Vitamin E (alpha Tocopherol)
- Vitamin K (Menadione, Phytonadione)

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, discussed vitamin A and niacin as causes of liver injury, but not the other B vitamins, vitamin C, D, E or K).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins).
Shils ME, Olson JA, Shike M, Ross AC. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998. (Textbook of nutrition with individual chapters on each of vitamins).
Food and Nutrition Board, Institute of Medicine. Dietary reference intakes. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on reference values for vitamin intake; replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/list-all/ (Fact sheets on dietary supplements including vitamins maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).

## OTHER REFERENCE LINKS

1 Recent References on Vitamins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamins/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vitamins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamins)